# Scopolamine

## OVERVIEW

### Introduction

Scopolamine as a natural plant alkaloid that has potent anticholinergic effects and is used to treat mild to moderate nausea, motion sickness and allergic rhinitis. Scopolamine has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Scopolamine (skoe pol' a meen) is a derivative of natural alkaloid found in plants of the nightshade family (henbane, jimson weed). Scopolamine has potent anticholinergic activity and broadly and nonspecifically inhibits muscarinic transmission. It has been used for decades as an antiemetic, antisecretory and antispasmotic agent in the treatment of nausea, motion sickness, allergic rhinitis, duodenal ulcer disease, gastrointestinal upset and spasm, functional bowel syndrome and hyperactive bladder. Semisynthetic derivatives include methscopolamine which is a quaternary ammonium derivative, which makes it less like to cross the blood brain barrier. Scopolamine has been used in clinical medicine for decades, but many commercial forms have not been formally approved for many of their common indications in the United States. Scopolamine is available in tablets, syrups, elixirs, powders, transdermal patches and solutions for injection. It is usually combined with other agents in commercial products such as phenobarbital for gastrointestinal complaints (Donnatal) and chlorpheniramine and phenylephedrine for allergic rhinitis (Allerx, Rescon). A transdermal patch is available for prevention of perioperative nausea and vomiting (1.5 mg: Transderm Scop). The recommended adult oral dose varies, but is generally 0.4 to 0.8 mg two to four times daily. Common side effects are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, headache, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety, restlessness and in some instances agitation and delusions (scopolamine madness). Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Despite widespread use over many decades, neither scopolamine nor methscopolamine have been linked to episodes of liver enzyme elevations or clinically apparent liver injury. Scopolamine is metabolized by the liver, but is usually given in low doses (<1 mg) for short periods only.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on Anticholinergic Agents.

Drug Class: Gastrointestinal Agents; Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methscopolamine – Generic, Pamine®

Scopolamine – Generic, TransdermScop®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Scopolamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Methscopolamine | 13265-10-6 | C18-H24-N-O4 | Scopolamine Chemical Structure
Scopolamine | 51-34-3 | C17-H21-N-O4 | Methscopolamine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Scopolamine, Methscopolamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Scopolamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Scopolamine, Methscopolamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Scopolamine)